# Sotorasib

## OVERVIEW

### Introduction

Sotorasib is a small molecule inhibitor of the KRAS G12C mutant protein which is found in up to 13% of refractory cases of non-small cell lung cancer. Serum aminotransferase elevations are common during therapy with sotorasib, and a proportion of patients develop clinically apparent liver injury that can be severe.

### Background

Sotorasib (soe toe ras’ ib) is an orally available, small molecule inhibitor of the KRAS gene product which is a frequently mutated oncogene found in several forms of cancer, most commonly in non-small cell lung cancer (NSCLC). The KRAS (Kristen rat sarcoma viral oncogene homolog) G12C mutation produces a constituently produced protein that stimulates excessive cell growth. Sotorasib binds to and inhibits the abnormal KRAS gene product and is a potent inhibitor of cell growth and proliferation in tumor cell lines and experimental tumor models with the KRAS G12C mutation, the first inhibitor of this oncogene protein. In large open label trials, sotorasib was found to induce objective responses in 36% of patients with refractory NSCLC harboring the KRAS G12C mutation. Sotorasib was granted accelerated approval in the U.S. in 2019 for adults with NSCLC with documented KRAS G12C mutations. It remains under evaluation for other forms of cancer harboring KRAS G12C mutations. Sotorasib is available in tablets of 120 and 320 mg under the brand name Lumakras. The recommended dose is 960 mg orally once daily until disease progression or unacceptable toxicity. Side effects are common and arise in almost all patients treated with sotorasib and lead to dose modification or discontinuation in approximately one-third of treated patients. Common side effects include diarrhea, nausea and vomiting, abdominal pain, fatigue, myalgia, arthralgia, cough, dyspnea, lymphopenia, anemia, and aminotransferase elevations. Uncommon but potentially severe adverse events include hepatotoxicity, interstitial lung disease and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of sotorasib in patients with solid tumors harboring KRAS G12C mutations, liver test abnormalities were frequent although usually self-limited and mild. Some degree of ALT elevations arose in 38% of sotorasib treated patients and were above 5 times the upper limit of normal (ULN) in 6% to 7%. In these trials that enrolled approximately 427 patients, sotorasib was discontinued early due to increased AST or ALT in 8% of patients. In addition, a small proportion of patients developed significant hepatotoxicity requiring sotorasib discontinuation and treatment with corticosteroids. The liver test abnormalities had a median onset of 9 weeks after initiation of therapy. While serum aminotransferase elevations were occasionally quite high (5 to 20 times upper limit of normal), there was no accompanying elevations in serum bilirubin and no patient developed clinically apparent liver injury with jaundice. The product label for sotorasib recommends monitoring for routine liver tests before, at 3 week intervals during the first 3 months of therapy, and monthly thereafter as clinically indicated.

Strikingly, the more severe elevations of serum aminotransferase levels during therapy with sotorasib occurred among patients who had recently received checkpoint inhibitor therapy (usually anti-PD-L1) in the 1 to 3 months before starting sotorasib. Furthermore, the elevations tended to respond quickly to corticosteroid therapy and sometimes did not recur when sotorasib was restarted several months later. These findings suggest that the aminotransferase elevations during sotorasib therapy are due to a delayed immune-mediated hepatotoxicity triggered by the previous checkpoint inhibitor therapy.

Likelihood score: D (possible but infrequent cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from sotorasib is unknown, but the pattern of abnormalities suggests immune-mediated liver injury. Several retrospective analyses have found that significant ALT and AST elevations arise most frequently in patients who had received checkpoint inhibitor therapy (usually anti-PD-L1) within 3 months of starting sotorasib. Furthermore, the histologic and clinical features of liver injury from sotorasib resemble that of checkpoint inhibitors and a limited course of corticosteroids is often found to be beneficial.

Sotorasib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity. Because of its known toxicity, drugs that inhibit CYP 3A4 activity should be avoided or the dose of sotorasib adjusted according.

### Outcome and Management

The product label for sotorasib recommends monitoring for routine liver tests before starting treatment, at 3 week intervals during the first 3 months of treatment and monthly thereafter as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to dose reduction or temporary cessation of sotorasib therapy and careful monitoring. If serum aminotransferase levels remain high, a limited course of corticosteroids may be appropriate, particularly if there is a history of prior check point inhibitor therapy or accompanying signs of hypersensitivity are present. Furthermore, restarting therapy in a reduced dose can be done with caution and continued monitoring. In patients with jaundice or symptoms of liver injury accompanying the serum aminotransferase elevations, sotorasib should be promptly discontinued. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of sotorasib with other antineoplastic small molecule inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sotorasib – Lumakras®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sotorasib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Sotorasib | 2296729-00-3 | C30-H30-F2-N6-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 02 September 2023

Abbreviations: KRAS, Kirsten rat sarcoma viral oncogene homolog; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of small molecule enzyme and receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss sotorasib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214665Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of sotorasib; states that the overall objective response rate was 36% and virtually all patients treated [n=204] had at least one adverse event and 50% had a serious adverse event, 38% of patients had an ALT elevation, 6% were above 5 times ULN, and there were many instances of hepatotoxicity [25%], which led to the early discontinuation in 5% but there were cases of acute liver injury with jaundice or hepatic failure and no fatalities due to liver injury).
Hong DS, Fakih MG, Strickler JH, Desai J, Durm GA, Shapiro GI, Falchook GS, et al. KRAS^G12C^ inhibition with sotorasib in advanced solid tumors. N Engl J Med. 2020;383(13):1207-1217. (Among 129 patients with refractory solid tumors harboring KRAS p.G12C mutations treated with escalating doses of sotorasib followed by a maintenance dose of 960 mg daily, the objective response rate was 32% in those with NSCLC, but was 7% in colorectal cancer and less than 15% in pancreatic and other cancers, while adverse events arose in 97% patients and were serious in 45% with ALT elevations in 12%, which were above 5 times ULN in 5% leading to discontinuation in only 1 patient). 32955176
Skoulidis F, Li BT, Dy GK, Price TJ, Falchook GS, Wolf J, Italiano A, et al. Sotorasib for lung cancers with KRAS p.G12C mutation. N Engl J Med. 2021;384:2371-2381. (Among 126 adults with refractory advanced or metastatic NSCLC with KRAS G12C mutations treated with sotorasib [960 mg daily], the objective response rate was 37% and adverse events were common [99%], which included treatment related ALT elevations in 21% that were above 5 times ULN in 6%). 34096690
Begum P, Goldin RD, Possamai LA, Popat S. Severe immune checkpoint inhibitor hepatitis in KRAS G12C-mutant NSCLC potentially triggered by sotorasib: case report. JTO Clin Res Rep. 2021;2:100213. (62 year old man with NSCLC and KRAS G12C mutation had received a single cycle of pembrolizumab and pemetrexed with further progression, was started on sotorasib [960 mg daily], and 2 weeks later developed marked elevations in ALT [initially 950 rising to 1722 UL], Alk P [initially 580 rising to 1326 U/L], and bilirubin [initially normal rising to 12 mg/dL], liver biopsy showing hepatitis with marked portal and lobular inflammation and bile duct damage, which responded slowly to corticosteroid therapy and ultimately resolved except for persistent mild-to-moderate Alk P elevations). 34590053
McCoach CE, Rolfo C, Drilon A, Lacouture M, Besse B, Goto K, Zhu VW, et al. Hypersensitivity reactions to selpercatinib treatment with or without prior immune checkpoint inhibitor therapy in patients with NSCLC in LIBRETTO-001. J Thorac Oncol. 2022;17:768-778. (Among 326 adults with NSCLC treated with selpercatinib, 22 [7%] developed a hypersensitivity reaction, generally within 1-3 weeks of starting therapy and responding rapidly to corticosteroid therapy, reactions arising in 17 of 152 patients [11%] who had previously received check point inhibitor therapy compared to 5 of 177 patients [3%] who had not). 35183775
Kinahan H. A rare event of liver dysfunction on sotorasib and management strategy. J Adv Pract Oncol. 2022;13:812-815. (A 76 year old man with refractory [to recent anti-PD-L1 therapy] metastatic lung cancer developed ALT elevations [541 U/L, bilirubin and Alk P not provided] after 9 weeks of oral sotorasib [960 mg daily], ALT returning to normal values within 4 weeks of stopping but rising again 3 weeks after restarting at full dose [ALT 937 U/L], again returning to normal with stopping and again rising with restarting at a lower dose, but after a tapering course of corticosteroids, he later was able to tolerate full doses with normal serum enzymes for more than a year). 36727020
Fakih MG, Kopetz S, Kuboki Y, Kim TW, Munster PN, Krauss JC, Falchook GS, et al. Sotorasib for previously treated colorectal cancers with KRAS^G12C^ mutation (CodeBreaK100): a prespecified analysis of a single-arm, phase 2 trial. Lancet Oncol. 2022;23:115-124. (Among 62 adults with KRAS G12C mutated refractory, advanced colorectal cancer treated with sotorasib [960 mg daily], the objective response rate was 9%, while treatment related adverse events occurred in 56% including ALT elevations in 4 patients [7%] which were above 5 times ULN in only 1 [2%]). 34919824
Chour A, Denis J, Mascaux C, Zysman M, Bigay-Game L, Swalduz A, Gounant V, et al. Brief report: severe sotorasib-related hepatotoxicity and non-liver adverse events associated with sequential anti-programmed cell death (ligand)1 and sotorasib therapy in KRAS^G12C^-mutant lung cancer. J Thorac Oncol. 2023;18(10):1408-1415. (Among 102 adults with refractory advanced NSCLC and KRAS G12C mutations treated with sotorasib in France outside of clinical trials, 48 who had received check point inhibitor therapy with anti-PD-L1 immediately before sotorasib, had higher rates of severe adverse events [50% vs 13%] and higher rates of ALT elevations above 5 times ULN [33% vs 11%], although no fatal instances of hepatotoxicity occurred). 37217096
de Langen AJ, Johnson ML, Mazieres J, Dingemans AC, Mountzios G, Pless M, Wolf J, et al.; CodeBreaK 200 Investigators. Sotorasib versus docetaxel for previously treated non-small-cell lung cancer with KRAS^G12C^ mutation: a randomised, open-label, phase 3 trial. Lancet. 2023;401(10378):733-746. (Among 345 adults with refractory, advanced NSCLC with a KRAS G12C mutation who were treated with sotorasib or docetaxel for a median of 18 months, progression-free survival was greater with sotorasib [5.6 vs 4.5 months] and serious adverse event rates were lower [11% vs 23%], although ALT elevations were more frequent with sotorasib [10% overall and 5% above 5 times ULN] vs docetaxel [0% overall]). 36764316
Strickler JH, Satake H, George TJ, Yaeger R, Hollebecque A, Garrido-Laguna I, Schuler M, et al. Sotorasib in KRAS p.G12C-mutated advanced pancreatic cancer. N Engl J Med. 2023;388:33-43. (Among 38 adults with KRAS G12C-mutated, metastatic pancreatic cancer treated with sotorasib [960 mg daily] for a median of 18 weeks, the objective response rate was 21% and treatment related adverse events arose in 42%, while ALT elevations arose in only 1 patient [2%]). 36546651
Desai A, Rakshit S, Bansal R, Ashara Y, Potter A, Manochakian R, Lou Y, et al. Time from immune checkpoint inhibitor to sotorasib use correlates with risk of hepatotoxicity in non-small cell lung cancer: A brief report. Cancer Treat Res Commun. 2023;36:100743. (Among 31 patients with advanced, refractory KRAS G12C-mutated NSCLC treated with sotorasib, 10 [32%] developed ALT elevations above 5 times ULN during therapy, all 10 had received previous checkpoint inhibitor therapy [usually anti-PD-L1] and rates of ALT elevations were higher in those receiving checkpoint inhibitors within 30 days [3 of 4: 75%], than 30-90 days [7 of 11: 65%], or greater than 90 days [none of 13: 0%], suggesting that sotorasib triggers a delayed immune-mediated hepatotoxicity from anti-PD-L1 therapy if given within 3 months of stopping). 37531736
Sotorasib (Lumakras) for NSCLC. Med Lett Drugs Ther. 2023;65:e104-e105. (Concise review of the mechanism of action, clinical efficacy, safety and costs of sotorasib mentions that it can cause elevations in ALT, AST and Alk P as well as “hepatotoxicity” for which reason monitoring of liver tests is recommended).

## OTHER REFERENCE LINKS

1. Recent References on Sotorasib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sotorasib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sotorasib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sotorasib)